# Quinine

## OVERVIEW

### Introduction

Quinine is a natural cinchona alkaloid that has been used for centuries in the prevention and therapy of malaria. Quinine is also used for idiopathic muscle cramps. Quinine therapy has been associated with rare instances of hypersensitivity reactions which can be accompanied by hepatitis and mild jaundice.

### Background

Quinine (kwye' nine) is the major alkaloid contained in the powered bark of the South American cinchona tree. The powder of the cinchona tree bark was used by native Quechna Indians in Peru to treat fever and was introduced into Western medicine when Jesuit priests took samples to Europe. The major effect of the cinchona tree bark was against malaria. Quinine acts against the asexual erythrocytic forms of malaria, including Plasmodium vivax, malariae and falciparum and is gametosidal to P. vivax and malariae. The use of quinine for malaria has been largely replaced by chloroquine, which is more potent and better tolerated. However, quinine is still used intravenously in some instances of drug resistant P. falciparum. In addition, quinine has been used frequently for nocturnal leg cramps, although the data in support of its efficacy is controversial, and quinine by prescription is no longer approved for this use. Quinine is available in multiple generic forms in low doses as an over-the-counter medication and as tablets of 324 mg for therapy of malaria. The use and dosage for malaria treatment and prevention requires higher doses than are used for leg cramps. Regularly updated recommendations on the therapy of malaria including specific details on diagnosis, management, drug dosage and safety are available at the CDC website: http://www.cdc.gov/malaria/. Common side effects of quinine include headache, dizziness, blurred vision, gastrointestinal upset, thrombocytopenia and hypersensitivity reactions.

### Hepatotoxicity

There is little evidence that chronic quinine therapy is associated with elevations in serum enzymes, although it has not been carefully assessed. However, there have been several reports of acute hypersensitivity reactions to quinine that include hepatic involvement. The reactions usually arise after 1 to 2 weeks of therapy, but can appear within 24 hours of restarting quinine or with rechallenge. The clinical features are marked by fatigue, nausea, vomiting, diffuse muscle aches, arthralgias and high fever. Blood testing at an early stage shows increases in serum aminotransferase and alkaline phosphatase levels as well as mild jaundice, which can deepen for a few days even after stopping quinine. The pattern of serum enzymes elevations is typically cholestatic or mixed. Rash is uncommon and eosinophilia is not typical, despite the presence of other signs of hypersensitivity (fever, arthralgias). Autoantibodies are not typically found. Liver biopsies usually show mild injury and small epithelioid granulomas, as are typically found in many organs during systemic hypersensitivity reactions. A similar clinical signature of liver injury occurs with quinidine, an optical isomer of quinine that is used predominantly as an antiarrhythmic.

Likelihood score: B (highly likely cause of clinically apparent liver injury).

### Mechanism of Injury

The hepatotoxicity of quinine is clearly due to a hypersensitivity reaction and there is no evidence for a direct hepatotoxic effect. There is likely to be a genetic predisposition to this hypersensitivity.

### Outcome and Management

The hepatotoxicity of quinine is usually mild and resolves within 1 to 4 weeks of stopping. In many instances, jaundice and liver test abnormalities may worsen for a few days after stopping quinine, but fatalities have not been reported, and recovery is usually rapid. Because of the rapidity of recovery, therapy with corticosteroids is best avoided. There is cross reactivity to quinidine (the optical isomer of quinine which is used as an antiarrhythmic agent) and other exposures to quinine should be avoided. Because quinine is in tonic water as well as many over-the-counter medications, medicinal foods and herbal preparations, patients with quinine sensitivity should make sure that they are not inadvertently exposed.

Drug Class: Antimalarial Agents

## CASE REPORT

### Case 1. Acute hypersensitivity and cholestatic jaundice due to quinine.

[Modified from: Farver DK, Lavin MN. Quinine-induced hepatotoxicity. Ann Pharmacother 1999: 33: 32-4. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/9972382)]

A 57 year old woman was given quinine for nocturnal leg cramps and developed high fever, chills, fatigue, muscle aches and nausea necessitating hospital admission within 24 hours of starting quinine. She had a history of hypertension, diabetes, hyperlipidemia and coronary artery disease for which she was taking insulin, lisinopril, amlodipine, aspirin, furosemide and multivitamins. She used acetaminophen occasionally. She did not drink alcohol and had no risk factors for acquiring viral hepatitis. On examination, she was febrile (39.5 ^o^C), but without rash, lymphoadenopathy or signs of acute or chronic liver disease. Laboratory testing showed normal blood counts, but elevations in alkaline phosphatase and aminotransferase levels without hyperbilirubinemia (Table). Tests for hepatitis A and B were negative as were autoantibodies. Her serum enzymes remained elevated and several days later she became jaundiced. Endoscopic retrograde cholangiopancreatography showed that the biliary tree was normal and the gallbladder was without gallstones. Quinine had been continued during the hospitalization, but was stopped on day 6, whereupon her symptoms began to improve. Hyperbilirubinemia resolved within a few days of stopping quinine and serum enzymes were normal or near normal 2 weeks later.

#### Key Points

Medication: | Quinine
Pattern: | Cholestatic (R=2.0→1.2)
Severity: | 3+ (jaundice, hospitalization)
Latency: | 1 day
Recovery: | 3 weeks
Other medications: | Insulin, lisinopril, amlodipine, aspirin, furosemide, and multiple vitamins chronically, occasional acetaminophen

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
| | Started quinine (260 mg at bedtime)
1 days | | 184 | 192 | 0.7
3 days | | | 185 | 0.9
4 days | | 226 | 303 | 1.2
5 days | | 368 | 528 | 2.6
6 days | 0 | 356 | 634 | 3.5 | Quinine stopped
8 days | 2 days | 235 | 642 | 1.0
2 weeks | 8 days | 71 | 500 | 0.2
3 weeks | 17 days | 27 | 214 | 0.6
Normal Values | | <55 | <117 | <1.2

#### Comment

A dramatic hypersensitivity reaction with jaundice, following a single dose of quinine in a patient without a known history of previous exposure. Improvement was prompt once quinine was stopped.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Quinine – Generic, Qualaquin®

DRUG CLASS

Antimalarial Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Quinine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Quinine | 130-95-0 | C20-H24-N2-O2 | Chemical Structure for Quinine

## ANNOTATED BIBLIOGRAPHY

References updated: 15 May 2018

Zimmerman HJ. Antiprotozoal agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 623-5. (Expert review of hepatotoxicity published in 1999; mentions that quinine is an ancient drug that has been incriminated in rare instances of granulomatous hepatitis).
Vinetz JM, Clain J, Bounkeua V, Eastman RT, Fidock D. Chemotherapy of malaria. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1383-418. (Textbook of pharmacology and therapeutics).
Colding H. Et tilfaelde af kinidinallergi med feber og leverpavirkning. [A case of quinine-allergy with fever and liver injury]. Ugeskr Laeger 1969; 131: 1657-8. (74 year old woman developed fever and fatigue 2-3 weeks after starting quidinine with rise in bilirubin [0.4 to 2.0 mg/dL], AST [0.7 to 7.3 units] and Alk P [2.2 to 10.5 units] and resolution within 1 week of stopping; positive rechallenge). 5365434
Deisseroth A, Morganroth J, Winokour S. Quinidine-induced liver disease. Ann Intern Med 1972; 77: 595-7. (77 year old developed fever 11 days after starting quinidine followed by increases in ALT to ~210 U/L and LDH to 310 U/L, with prompt improvement upon stopping and recurrence of fever and ALT elevations within 24 hours of rechallenge). 4642741
Winkler JW. Quinidine hepatotoxicity? Ann Intern Med 1973; 78: 460. (Letter in response to Deisseroth et al. [1972] raising the issue of role of dioctyl calcium sulfosuccinate [Surfak] in the hepatic injury; authors reply that this was unlikely). 4694908
Murphy RJ, Rymer W. Quinidine induced liver disease? Ann Intern Med 1973; 78: 460. (62 year old man with 3 episodes of fever which in retrospect was thought to be due to quinidine with AST elevations of ~135 U/L, given challenge dose and developed fever to 39.4 ^o^C but no change in AST). 4694908
Chajek T, Lehrer B, Geltner D, Levij IS. Quinidine-induced granulomatous hepatitis. Ann Intern Med 1974; 81: 774-6. (69 year old man developed fever 7 days after starting quinidine [bilirubin 1.0 mg/dL, Alk P 205 U/L, AST 430 U/L] resolving within 1 week; rechallenge led to fever within 24 hours and rise of AST to 250 U/L, Alk P 305 U/L, biopsy showing granulomas, repeat rechallenge showing the same with biopsy before and after). 4433082
Chajek T. Quinidine and granulomatous hepatitis. Ann Intern Med 1975; 82: 282. (After 1974 article, saw another case: 64 year old man developed fever 12 days after starting quinidine with Alk P and AST elevations, with rapid improvement on stopping and recurrence on restarting, biopsy showing granulomas). 1115455
Handler SD, Hirsch NR, Hass K, Davidson FZ. Quinidine hepatitis. Arch Intern Med 1975; 135: 871-2. (72 year old woman developed abnormal liver tests [AST 367 U/L] 7 months after starting quinidine, remaining elevated for 9 months and AST rising to 800 U/L [no jaundice and Alk P peak 110 U/L], rapid improvement with stopping and positive rechallenge to one dose with symptoms and AST rising to 110 U/L). 48362
Koch MJ, Seeff LB, Crumley CE, Rabin L, Burns WA. Quinidine hepatitis: a report of a case and review of the literature. Gastroenterology 1976; 70: 1136-40. (47 year old man developed fever and abdominal pain 10 days after starting quinidine [normal bilirubin, peak ALT 910 U/L, Alk K 210 U/L], resolving rapidly when quinidine was stopped, and with recurrence of symptoms and mild ALT elevation within days of rechallenge). 1269875
Geltner D, Chajek T, Rubinger D, Levij IS. Quinidine hypersensitivity and liver involvement: a survey of 32 patients. Gastroenterology 1976; 70: 650-2. (Among 487 patients who received quinidine over a 4 year period, 32 [6.5%] developed a hypersensitivity reaction including 10 [2%] with liver involvement with fever, Alk P and AST elevations and jaundice in half, usually after 4-14 days of therapy, resolving rapidly, liver biopsies showing granulomas and focal necrosis). 1261756
Dzur JR. Letter: Quinidine hepatotoxicity. JAMA 1976; 235: 908. (Patient developed jaundice one month after starting quinidine, resolving with stopping; no details given). 946110
Rotmensch HH, Rubinstein A, Livni E, Liron M, Ilie B. [Quinidine-induced subclinical hepatitis]. Harefuah. 1980; 98: 211-2. Hebrew. (68 year old man developed fever and arthralgias within weeks of starting quinidine, liver tests were normal but liver biopsy showed small granulomas and spotty hepatocyte necrosis; fever resolved within 7 days of stopping quinidine). 6997146
Bramlet DA, Posalaky Z, Olson R. Granulomatous hepatitis as a manifestation of quinidine hypersensitivity. Arch Intern Med 1980; 140: 395-7. (64 year old woman developed fever and fatigue one month after starting quinidine [bilirubin 1.8 mg/dL, ALT 327 U/L, Alk P 105 U/L], rapid resolution and positive rechallenge in one day with fever and AST elevation, underwent 3 liver biopsies showing presence, disappearance and reappearance of small granulomas). 7362358
Tiliakos N, Waites TF. Multiform quinidine toxicity. South Med J 1981; 74: 1267-8. (39 year old man developed fever and fatigue 8 days after starting quinidine with rash [4% eosinophils, thrombocytopenia, bilirubin 4.0 mg/dL, AST 280, Alk P 150 U/L], with rapid improvement on stopping quinidine). 7197395
Slezak P. Quinidine hepatotoxicity. Med J Aust 1981; 1: 139. (58 year old man developed fever, fatigue and abdominal pain 10 days after starting quinidine, followed by jaundice [bilirubin 1.6 mg/dL, ALT 208 U/L, Alk P 1.5 times ULN]). 7219288
Karoly R, Ferenc S. [An unusual side effect of quinidine: liver damage, pneumonia]. Orv Hetil 1983; 124: 055-6. Hungarian. (59 year old man developed fever, liver injury and pneumonitis within days of starting quinidine [bilirubin 3.1 mg/dL, ALT 120 U/L, Alk P 183 U/L, 6% eosinophils]). 6634153
Urdahl P, Bjørkheim A. [Quinidine-induced hepatitis. A case report and review of the literature]. Tidsskr Nor Laegeforen 1983; 103: 760-3. Norwegian. (60 year old woman developed fever and fatigue within a week of starting quinidine [bilirubin 2.7 mg/dL, ALT 292 U/L, Alk P 229 U/L], with rapid recovery and positive rechallenge). 6879565
Katz B, Weetch M, Chopra S. Quinine-induced granulomatous hepatitis. Br Med J 1983; 286: 264-5. (65 year old woman with episodic fever, nausea and polyarthralgias during 5 months of intermittent quinine use for leg cramps, [bilirubin 0.5 mg/dL, ALT 460 U/L, Alk P 375 U/L], biopsy showing granulomas; positive rechallenge with fever and ALT to 480 U/L). 6402064
Nirodi NS. Quinine induced granulomatous hepatitis. Br Med J(Clin Res Ed) 1983; 286: 647. (Letter questioning the presence of granulomas in case of Katz et al. [1983]). 6402190
Smally AJ. When to leave well enough alone—two cases. Hosp Pract 1985; 20: 48-9. (Two cases of quinidine hepatotoxicity; first case with nausea and fever 10 days after starting quinidine followed by jaundice [bilirubin 5.4 mg/dL, AST 168 U/L, 3-4% eosinophils], and rapid recovery upon stopping; second with onset of fever, fatigue and headache 3 weeks after starting quinidine [ALT 121 U/L], rapid resolution upon stopping). 3918052
Tanaka N, Matsushita E, Morimoto H, Kobayashi K, Hattori N. [Toxic hepatitis induced by cardiovascular agents]. Nippon Rinsho 1985; 43: 1172-5. Japanese. (Case series of drug induced liver disease due to cardiovascular agents, including one case due to quinidine). 3900470
Knobler H, Levij IS, Gavish D, Chajek-Shaul T. Quinidine-induced hepatitis: a common and reversible hypersensitivity reaction. Arch Intern Med 1986; 146: 526-8. (Among 90 cases of drug induced liver injury seen over 10 years in one referral hospital in Israel, 33 were due to quinidine [2% of recipients] with typical signature of fever, arising within first 4 weeks of therapy, both Alk P and ALT modestly elevated, only 6 with jaundice, none fulminant, all resolved rapidly with no long term consequences; 8 rechallenged and all redeveloped fever, 6 had Alk P and AST elevations as well). 3954525
Zatuchni J. Quinidine-induced hepatitis. Arch Intern Med 1986; 146: 2077, 2081. (Letter questioning Knobler et al. [1986] why quinidine was used so much in view of its questionable efficacy; reply by authors). 3767557
Pariente EA, Maitre F, Marchand JP. [Hepatitis caused by quinidine. Study of a case and review of the literature]. Gastroenterol Clin Biol 1986; 10: 255-8. French. (63 year old woman developed fatigue and jaundice 1 month after starting quinidine [bilirubin 2.2 mg/dL, ALT 109 U/L, Alk P 684 U/L], biopsy showing granulomas, rapid recovery but still had hepatomegaly and elevated Alk P in follow up). 3732735
Bourlière M, Bernuau J, Rueff B, Benhamou JP. Quinidine phenylethyl-barbiturate-induced fulminant hepatitis in a pregnant woman. A case report. J Hepatol 1988; 6: 214-6. (19 year old pregnant woman developed rash and fever one month after starting quinidine and barbiturate [bilirubin 1.6 rising to 18.8 mg/dL, ALT 296 to 800 U/L, Alk P 267 U/L, prothrombin index 13%], delivering normal baby, but subsequently developing hepatic failure and undergoing successful liver transplant). 3411101
Alix M, Mosquet B, Adrien A, Cuny G, Raffy P, Moulin M. [Cholestatic hepatitis caused by quinidine phenylethylbarbiturate, and sarcoidosis. Apropos of a case]. Therapie 1989; 44: 69. French. (68 year old developed jaundice 2 months after starting quinidine and a barbiturate with mild fever [bilirubin 15 mg/dL, ALT 200 U/L, Alk P 342 U/L], which improved with stopping, but enzymes remained high and follow up liver biopsy suggested sarcoidosis). 2734725
Mathur S, Dooley J, Scheuer PJ. Quinine induced granulomatous hepatitis and vasculitis. BMJ 1990; 300: 613. (67 year old man with fever, rash and polyarthralgias after 2 months of intermittent quinine therapy for leg cramps [bilirubin 0.6 mg/dL, AST 100 U/L, Alk P 1668 U/L], granulomas on biopsy and rapid recovery upon stopping). 2108777
Punukollu RC, Kumar S, Mullen KD. Quinine hepatotoxicity: an under recognized or rare phenomenon? Arch Intern Med 1990; 150: 1112-3. (37 year old woman developed fever, headache, arthralgias and abdominal pain without rash 2-3 weeks after starting quinine for leg cramps [bilirubin 1.8 mg/dL, ALT 128 U/L, Alk P 327 U/L, eosinophils 6%], rapid improvement with stopping quinine, normal in 1 week; positive rechallenge to one dose with fever and ALT to 64 U/L). 2331190
Perez JA, Stryker J, Arsura EL, Hewitt JM. Probable quinine-induced hepatotoxicity. West J Med 1994; 160: 59-60. (74 year old man developed fever, abdominal pain and jaundice one month after starting quinine for leg cramps [bilirubin 7.2 mg/dL, ALT 241 U/L, Alk P 314 U/L, ESR 65], biopsy showing granulomas and resolving rapidly upon stopping). 8128710
Man-Song-Hing M, Wells G. Meta-analysis of efficacy of quinine for treatment of nocturnal leg cramps in elderly people. BMJ 1995; 10: 13-7. (Meta analysis of 107 patients from 6 clinical trials; quinine reduced number of nights without leg cramps by 27%). 7827545
Horney E, Lagerstedt C, Wadenvik H. [Quinine induced thrombocytopenia and granulomatous hepatitis]. Lakartidningen 1996; 93: 361-4. Swedish. (58 year old man developed intermittent fevers [normal bilirubin, ALT 185 U/L, GGT 145 U/L, thrombocytopenia]; positive rechallenge). 8628066
Hou M, Horney E, Stockelberg D, Jacobsson S, Kutti J, Wadenvik H. Multiple quinine-dependent antibodies in a patient with episodic thrombocytopenia, neutropenia, lymphocytopenia, and granulomatous hepatitis. Blood 1997; 90: 4806-11. (58 year old man with recurrent, transient bouts of fever, nausea, thrombocytopenia and ALT elevations [4-6 times ULN] shown to be due to intermittent exposure to quinine, with positive rechallenge and demonstration of quinine dependent antibodies to platelets and white blood cells). 9389697
Farver DK, Lavin MN. Quinine-induced hepatotoxicity. Ann Pharmacother 1999: 33: 32-4. (57 year old woman developed fever, nausea and myalgias within 24 hours of starting quinine for leg cramps with temperature 39.5 ^o^C [bilirubin 0.7 mg/dL, ALT 184 U/L, Alk P 192 U/L], resolving in 3 weeks). 9972382
Howard MA, Hibbard AB, Terrell DR, Medina PJ, Vesely SK, George JN. Quinine allergy causing acute severe systemic illness: report of 4 patients manifesting multiple hematologic, renal, and hepatic abnormalities. Proc (Bayl Univ Med Cent) 2003; 16: 21-6. (Four case reports of quinine induced thrombocytopenia with other systemic manifestations, including prominent AST [131, 992, 741 and 3735 U/L] and mild Alk P [74-170 U/L] elevations and 2 with jaundice [bilirubin 4.3 and 16.1 mg/dL]; often inadvertent quinine use from over-the-counter pills). 16278718
Schlegel A. Factitious granulomatous hepatitis? Am J Med 2004; 116: 500-1. (35 year old woman with relapsing episodes of fever, abdominal pain and ALT elevations [1488 U/L] and biopsy showing small granulomas, finally confessed to intermittent, purposeful use of quinine). 15047046
Taylor WR, White NJ. Antimalarial drug toxicity: a review. Drug Saf 2004; 27: 25-61. (Review of toxicities and safety of antimalarials: quinine can cause a characteristic hypersensitivity reaction with liver injury). 14720085
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, no cases were attributed to quinine or quinidine). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Quinine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=quinine+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Quinine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=quinine)